# Valerian

## OVERVIEW

### Introduction

Valerian is a botanical extract derived from the roots of Valeriana officinalis, which is widely used in herbal medicine for insomnia, anxiety and digestive and urinary problems. Valerian has been linked to rare instances of clinically apparent liver injury.

### Background

Valerian (va ler' ee an) is the common name of the plant genus Valeriana, several species of which are used in herbal medicine, most typically Valeriana officinalis. Valerian has been used for centuries in Europe, usually for digestive and urinary problems. The name valerian derives from the Latin word valere, which means “to be in good health.” Valerian is claimed to have sedative, hypnotic, anxiolytic, anticonvulsant, antispasmodic and antidepressant activities. Presently, it is used most commonly as a sleeping aid and for therapy of stress. The basis for its sedative effects is believed to be valepotriates (which are terpene alcohols) and volatile oils (including monoterpenes and sesquiterpenes). Components of valerian are believed to interact with the gamma amino butyric acid (GABA) receptor in a manner similar to the benzodiazepines. The typical dosage of valerian is 300 to 600 mg at bedtime for sleep or taken 3 times daily for stress. Valerian is found in many relaxation drinks. Valerian has few side effects, which are mostly mild and transient and include sedation, dizziness and withdrawal symptoms on stopping.

### Hepatotoxicity

Valerian has been implicated in a small number of cases of clinically apparent liver injury, but usually in combination with other botanicals such as skullcap or black cohosh. In view of its wide scale use, valerian has to be considered a very rare cause of hepatic injury. In published cases, the latency to onset ranged from 3 to 12 weeks and the pattern of enzyme elevations was usually hepatocellular or mixed hepatocellular-cholestatic. The liver injury was usually mild-to-moderate in severity with recovery within 2 to 4 months of stopping. Immunoallergic and autoimmune features were not present. Severe cases with features of hepatic failure have been described, but usually in association with other potentially hepatotoxic herbals.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the liver injury associated with valerian use is not known. Valerian extracts contain multiple ingredients, but none have been shown to be specifically hepatotoxic.

### Outcome and Management

Hepatotoxicity from valerian is usually mild-to-moderate in severity and self-limiting. Only a small number of cases of liver injury attributed to valerian have been published, and there have been no instances of chronic hepatitis, cirrhosis or vanishing bile duct syndrome attributed to its use, and no convincing case of acute liver failure.

Other Names: All-heal, Garden heliotrope, Tagara, Valeriana officinalis, Common valerian, Garden valerian, Indian valerian

Drug Class: Herbal and Dietary Supplements

## CASE REPORT

### Case 1. Acute hepatitis due to valerian.(1)

A 57 year old woman developed fatigue one week after starting an herbal medication for stress (Neurelax: believed to contain valerian, hops, asafetida and gentian). Two weeks later, 3 weeks after starting the botanical, she developed jaundice. She had no history of liver disease or risk factors for viral hepatitis. She drank socially, averaging 1 to 2 alcoholic beverages daily, and took no other medications except indapamide (a nonthiazide diuretic) which she had taken for many years. Physical examination showed jaundice, but no fever, rash or signs of chronic liver disease. Laboratory tests showed marked elevations in serum bilirubin (18.4 mg/dL) and ALT levels (1165 U/L) (Table). There was no mention of results of testing for viral or autoimmune hepatitis. Ultrasonography showed no evidence of biliary obstruction. Despite stopping the herbal, she deteriorated clinically over the next few weeks, developing ascites and hepatic encephalopathy. The jaundice persisted for 4 months but eventually resolved. A liver biopsy showed evidence of chronic hepatitis and fibrosis. Ten months after initial presentation, she was well enough to return to work, but serum ALT levels were still slightly elevated.

#### Key Points

Medication: | Neurelax (Valerian)
Pattern: | Hepatocellular (R=12.7)
Severity: | 4+ (jaundice, hospitalization, hepatic decompensation)
Latency: | 1 week to fatigue, 3 weeks to jaundice
Recovery: | 10 months (incomplete)
Other medications: | Indapamide chronically

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
Supplement started
3 weeks | 0 | 1165 | 232 | 18.4 | INR=1.9
4 weeks | 1 weeks | 890 | | 22.8
6 weeks | 3 weeks | 200 | | 23.4
8 weeks | 5 weeks | 210 | | 28.7
4 months | 10 weeks | 90 | | 6.1
5 months | 16 weeks | 95 | | 2.3
7 months | 24 weeks | 100 | | 1.2
Normal Values | | <40 | <100 | <1.2

* Some values estimated from Figure 1. Bilirubin levels converted by formula: 17.1 μmol/L=1.0 mg/dL.

#### Comment

While this case was convincing as an example of drug induced liver injury, the herbal responsible for the injury was somewhat unclear and it is always possible that the hepatic injury was due to a contaminant of the product. The clinical pattern was of an acute viral hepatitis-like illness with acute liver failure, but eventual partial recovery.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Valerian – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://nccih.nih.gov/health/valerian)

Fact Sheet at Office of Dietary Supplements, NIH (https://ods.od.nih.gov/factsheets/Valerian-HealthProfessional/)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Valerian | 8008-88-6 | Herbal mixture | No Structure

## CITED REFERENCE

1 MacGregor FB, Abernethy VE, Dahabra S, Cobden I, Hayes PC. (1989). Hepatotoxicity of herbal remedies. BMJ.

## ANNOTATED BIBLIOGRAPHY

References updated: 05 April 2020

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; hepatotoxicity of herbals is discussed, but valerian is not specifically mentioned).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS] Valerian is listed as a potential cause of hepatitis but is not specifically discussed).
Valerian. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 872-6. (Compilation of short monographs on herbal medications and dietary supplements).
MacGregor FB, Abernethy VE, Dahabra S, Cobden I, Hayes PC. (1989). Hepatotoxicity of herbal remedies. BMJ. (Four cases of hepatitis attributed to herbals, all women, ages 41 to 57, developed jaundice 2-8 weeks after starting herbals for stress [“Neurelax” and “Kalms”], believed to contain skullcap and/or valerian [bilirubin 13.5-28.3 mg/dL, ALT 293-1165 U/L, Alk P 97-730 U/L], resolving 2-19 months after stopping: Case 1).
Shepherd C. (1993). Sleep disorders. Liver damage warning with insomnia remedy. BMJ. (Letter in response to a review on the medical uses of valerian pointing out recent reports of hepatotoxicity [MacGregor 1989]).
Caldwell SH, Feeley JW, Wieboldt TF, Featherston PL, Dickson RC. (1994). Acute hepatitis with use of over-the-counter herbal remedies. Va Med Q. (53 year old woman developed jaundice 4 weeks after starting an herbal containing skullcap and valerian [4 capsules nightly] for sleep [bilirubin 9 mg/dL, ALT 1208 U/L, Alk P 298 U/L, protime 13.5 sec], resolving in 3 months).
Chan TY, Tang CH, Critchley JA. (1995). Poisoning due to an over-the-counter hypnotic, Sleep-Qik (hyoscine, cyproheptadine, valerian). Postgrad Med J. (Study of 23 patients who took an overdose of “Sleep-Qik”, a botanical containing valerian, demonstrated no evidence of ALT elevations or liver injury).
Shaw D, Leon C, Kolev S, Murray V. (1997). Traditional remedies and food supplements. A 5-year toxicological study (1991-1995). Drug Saf. (Five year experience of a Medical Toxicology Unit in London including 1297 enquiries and 37 for liver injury; 9 cases described, 5 due to valerian).
Mennecier D, Saloum T, Dourthe PM, Bronstein JA, Thiolet C, Farret O. (1999). Presse Med. (63 year old woman developed fatigue followed by jaundice several weeks after starting valerian as a sleep aid [bilirubin 4.2 mg/dL, ALT 352 U/L, Alk P 739 U/L], resolving in 3 months after stopping).
Plushner SL. (2000). Valerian: Valeriana officinalis. Am J Health Syst Pharm. (Review of the uses, pharmacology, clinical efficacy and safety of valerian with mention of report of 4 cases of possible hepatotoxicity [MacGregor 1989]).
Stevinson C, Ernst E. (2000). Valerian for insomnia: a systematic review of randomized clinical trials. Sleep Med. (Systematic review of efficacy and safety of valerian for insomnia concluded that evidence for efficacy of valerian is promising, but not fully conclusive; no mention of hepatotoxicity).
Stickel F, Seitz HK, Hahn EG, Schuppan D. (2001). Z Gastroenterol. (Review of hepatotoxicity of botanicals including pyrrolizidine alkaloids, germander, celandine, chaparral, Chinese herbs and pennyroyal).
Stedman C. (2002). Herbal hepatotoxicity. Semin Liver Dis. (Review and description of patterns of liver injury due to herbals, including discussion of potential risk factors, and herb-drug interactions; valerian is listed as potentially causing abnormal liver tests).
Whiting PW, Clouston A, Kerlin P. (2002). Black cohosh and other herbal remedies associated with acute hepatitis. Med J Aust. (6 cases of severe hepatitis in patients taking herbal medications, including one on black cohosh alone and 5 taking multiple herbals including skullcap [n=3], valerian [n=2], chaparral [n=1], and greater celandine [n=1] for 1 to 14 weeks, presenting with jaundice [bilirubin 9.9-62.7 mg/dL, ALT 1293-3764 U/L, Alk P 80-219 U/L], the one on black cohosh alone requiring emergency liver transplantation, the other 5 resolving in 7-25 weeks, 3 treated with prednisone for prolonged cholestasis).
Pittler MH, Ernest E. (2003). Systematic review: hepatotoxic events associated with herbal medicinal products. Aliment Pharmacol Ther. (Systematic review of published cases of hepatotoxicity due to herbal medications listing 52 case reports or case series, most common agents being celandine [3], chaparral [3], germander [8], Jin Bu Huan [3], kava [1], Ma Huang [3], pennyroyal [1], skullcap [2], Chinese herbs [9], valerian [1]).
Schiano TD. (2003). Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis. (Review of herbal associated hepatotoxicity, including common patterns of presentation; valerian is listed as having hepatotoxic potential).
Hadley S, Petry JJ. (2003). Valerian. Am Fam Physician. (The root of valerian is used mostly commonly as a sleeping aid, and secondarily as an anxiolytic; review of clinical trials; no discussion of hepatotoxicity).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were performed for drug induced acute liver failure, including 7 [5%] attributed to herbal medications, but valerian not mentioned as a cause).
Seeff LB. (2007). Herbal hepatotoxicity. Clin Liver Dis. (Review of herbal induced hepatotoxicity, with a review of the case series of acute liver injury attributed to valerian [MacGregor 1989]).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, one attributed to valerian, onset in 1 week [bilirubin 16.9 mg/dL, ALT and Alk P normal], resolving in 6 months).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications, but none were attributed to valerian).
Cohen DL, Del Toro Y. (2008). A case of valerian-associated hepatotoxicity. J Clin Gastroenterol. (27 year old woman developed fatigue and abdominal pain 10 weeks after starting valerian root [bilirubin 0.9 mg/dL, ALT 820 U/L, Alk P 278 U/L], resolving within 4 weeks of stopping).
Navarro VJ. (2009). Herbal and dietary supplement hepatotoxicity. Semin Liver Dis. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS; valerian is listed as having been linked to hepatotoxicity).
Vassiliadis T, Anagnostis P, Patsiaoura K, Giouleme O, Katsinelos P, Mpoumponaris A, Eugenidis N. (2009). Valeriana hepatotoxicity. Sleep Med. (50 year old woman found to have ALT elevations without symptoms 3 weeks after starting valerian tea [ALT 246 rising to 564 U/L with normal bilirubin and Alk P], resolving 10 months after stopping).
Müller Z, Sárkány A, Altorjay A, Szilágyi A, Tura T, Ozsvár Z. (2009). Orv Hetil. (50 year old woman with alcoholism who took valerian intermittently developed cirrhosis and portal hypertension, the authors suggesting that valerian exacerbated the underlying alcoholic cirrhosis).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry does not mention valerian or skullcap).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury, of which 12 [9%] were due to herbals including usnic acid [2], thermoslim [1], Ma Huang [1], horny goat weed [1], black cohosh [1], Hydroxycut products [1] and unspecified herbals [4], but none were attributed to valerian specifically).
Stacy S. (2011). Relaxation drinks and their use in adolescents. J Child Adolesc Psychopharmacol. (Review of relaxation drinks which now include more than 300 bottled beverages available in the US, some of which include valerian as an anxiolytic and sleeping aid with names such as Bula, Drank, iChill, Marley Mellow Mood, miniCHILLL, Slow Cow).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements including two publications on valerian [MacGregor 1989, Mennecier 1999]).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury mentions that valerian has been implicated in causing clinically apparent hepatotoxicity [Cohen 2008]).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 attributed to herbals or dietary supplements, but none specifically to valerian).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment; mentions that valerian containing products have been implicated in several cases of liver injury usually with a hepatocellular pattern).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, one was attributed to valerian).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of possible beneficial as well as harmful effects of herbal products on the liver mentions that valerian has been implicated in causing drug induced liver injury resembling an acute hepatitis).
Kia YH, Alexander S, Dowling D, Standish R. (2016). A case of steroid-responsive valerian-associated hepatitis. Intern Med J. (57 year old man developed jaundice 2 weeks after taking 3 tablets of a cold medication that included 2 grams of valerian in each [bilirubin 5.1 mg/dL, ALT 1191 U/L, Alk P 221 U/L, INR 1.3], enzymes not improving over the next 4 weeks when prednisolone was added with prompt resolution and continued normalization after it was stopped).
Schroeck JL, Ford J, Conway EL, Kurtzhalts KE, Gee ME, Vollmer KA, Mergenhagen KA. (2016). Review of safety and efficacy of sleep medicines in older adults. Clin Ther. (Extensive systematic review of medications for sleep mentions that valerian and melatonin are unrelated products that have a small impact on sleep latency and can produce residual sedation; no mention of adverse events except to say that side effects were no greater with valerian than with placebo in small efficacy trials).
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. (2016). Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci. (Listing of published cases of liver injury from HDS products, but does not list those attributed to valerian).
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, lists at least 3 reports of liver injury attributed to valerian, often in combination with other potential causes of liver injury Cohen [2008], Vassiliadis [2009], MacGregor [1989]).
de Boer YS, Sherker AH. (2017). Herbal and dietary supplement-induced liver injury. Clin Liver Dis. (Review of the frequency, clinical features, patterns of injury and outcomes of HDS hepatotoxicity with specific mention of anabolic steroids, black cohosh, germander, green tea, kava, pyrrolizidine alkaloids and proprietary multiingredient dietary supplements [MIDS], but does not specifically discuss valerian).
(2018). Drugs for chronic insomnia. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, side effects and costs of medications for chronic insomnia mentions valerian and other herbal therapies but LAO that “there is no convincing evidence that any of the “natural remedies” used for insomnia are effective or safe for this indication and the purity and optimal doses of all of these products is unknown”).

## OTHER REFERENCE LINKS

1 Recent References on Valerian: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Valerian+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Valerian: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Valerian)